# Fenbendazole

## OVERVIEW

### Introduction

Fenbendazole is a veterinary anthelmintic agent used predominantly to treat parasitic worm infestations in domestic cats and dogs. Fenbendazole is not approved for use in humans but has been claimed to have antineoplastic activity, and because the veterinary drug is available over the counter, it has been re-purposed and used off label to treat cancer. Fenbendazole therapy is commonly associated with mild and transient serum enzyme elevations and can also lead to clinically apparent acute liver injury.

### Background

Fenbendazole (fen ben' da zole) is a benzimidazole anthelmintic agent similar in structure and mechanism of action to albendazole and mebendazole but used in animals, including cattle, horses, pigs, and domestic cats and dogs to treat roundworm, whipworm, pinworm, and hookworm infections. The benzimidazoles act by selective binding to beta-tubulin of parasitic worms, causing their immobilization and death. Fenbendazole has proven efficacy against several parasitic worms but has not been approved for use in humans the United States. Fenbendazole has been studied in vitro and in animal models and claimed to demonstrate antineoplastic activity. However, it has not been shown to be effective in treating any form of cancer in humans. Nevertheless, fenbendazole has been claimed to have potential antineoplastic activity and is promoted on social media for use in patients with refractory cancers. Fenbendazole is available as veterinary medication over the counter in generic forms and under brand names such as Panacur and Safe Guard usually in tablets or granules in packets of 220 mg. A typical regimen is 220 mg daily four days per week. Fenbendazole is generally well tolerated; side effects of benzimidazoles include gastrointestinal upset, dizziness, headaches and hair loss. Uncommon, but potentially severe adverse reactions include bone marrow suppression, pancytopenia, granulocytopenia, sudden worsening of neurocysticercosis, hypersensitivity reactions, rash, erythema multiforme and Stevens Johnson syndrome.

### Hepatotoxicity

The side effects of fenbendazole therapy in humans have not been well described, but other benzimidazoles are associated with transient and asymptomatic elevations in serum aminotransferase levels in up to 50% of patients treated for more than a few weeks. These abnormalities rapidly improve with stopping therapy. Fenbendazole taken by patients without prescription for its purported antineoplastic activity has been associated with several instances of clinically apparent liver injury. The onset of injury has been within a few days to as long as a year after starting therapy or more rapidly with multiple courses of treatment. The pattern of serum enzyme elevations is typically hepatocellular or mixed. Allergic features (rash, fever, eosinophilia) may be present but are not prominent. Most cases have been mild to moderate in severity, and recovery is rapid once the drug is stopped. However, some cases have been severe and potentially life-threatening. Rapid recurrence with rechallenge has been reported with other benzimidazoles but with similar severity.

Likelihood score: C (probable cause of clinically apparent liver injury).

### Mechanism of Injury

Fenbendazole acts by binding tubulin in parasitic worms which it does with greater avidity than the tubulin in mammalian cells, but some of the toxicity of the benzimidazoles may be related to this tubulin-binding activity. In most instances of clinically apparent liver injury, hypersensitivity appears to be the cause. A similar mixed hepatitis with jaundice has been described in dogs receiving fenbendazole.

### Outcome and Management

The important first step in management of fenbendazole induced liver injury is to recognize that it is the cause and promptly discontinue its use. Patients typically take fenbendazole on their own initiative and without medical supervision. They may be hesitant to mention its use to their private physician or oncologist. Furthermore, liver injury is not uncommon during cancer chemotherapy, so that the injury initially may be attributed to one of the conventional antineoplastic agents or to the underlying malignancy. Patients who admit taking fenbendazole should be advised to have serum enzymes tested regularly, once or twice monthly. Patients with acute liver injury attributed to fenbendazole should avoid repeat exposure as recurrence is common.

Drug Class: Anthelmintic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Fenbendazole – Generic, Albenza®

DRUG CLASS

Anthelmintic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=fenbendazole)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Fenbendazole | 43210-67-9 | C15-H13-N3-O2-S

## ANNOTATED BIBLIOGRAPHY

References updated: 20 April 2026

Zimmerman HJ. Anthelminthics. Hepatic injury from antimicrobial agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 626-8. (Expert review of hepatotoxicity of anthelmintics written in 1999; fenbendazole is not discussed).
Keiser J, McCarthy J, Hotez PJ. Chemotherapy of helminth infections. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1001-7. (Textbook of pharmacology and therapeutics).
Morris DL, Smith PG. Albendazole in hydatid disease—hepatocellular toxicity. Trans R Soc Trop Med Hyg 1987; 81: 343-4. (Among 40 patients treated with albendazole for echinococcosis, 6 had ALT elevations [62-970 U/L, Alk P ~360 U/L] and 1 jaundice [bilirubin 5.7 mg/dL], with rapid resolution on stopping; 2 had positive rechallenge). 3617201
Drugs for parasitic infections. Treat Guidel Med Lett 2013; 11 (Suppl): e1-31. (Brief description of drugs for parasitic infections in adults and children as well as a table of their major side effects: albendazole is the drug of choice for ascariasis, cutaneous larva migrans, pinworm, hookworm, whipworm, trichinellosis, and several less common parasitic infections; side effects include ALT elevations).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin American published between 1996 and 2012, one case [non-fatal] was attributed to mebendazole, but none to albendazole or fenbendazole). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to anthelmintic agents). 25754159
Schwartz RD, Donoghue AR, Baggs RB, Clark T, Partington C. Evaluation of the safety of fenbendazole in cats. Am J Vet Res. 2000;61:330-2. (Among 28 cats given fenbendazole [50, 150 or 250 mg/kg] for 9 days [up to 5 times recommended dose for 3 times the recommended duration], there were no apparent adverse events and all biochemical and hematologic tests remained unchanged during and after therapy). 10714528
Yamaguchi T, Shimizu J, Oya Y, Horio Y, Hida T. Drug-induced liver injury in a patient with nonsmall cell lung cancer after the self-administration of fenbendazole based on social media information. Case Rep Oncol. 2021;14:886-891. (80 year old Japanese woman with lung cancer treated with pembrolizumab developed liver test abnormalities 1 month after starting fenbendazole [1 gm daily for 4 days a week] on her own initiative [bilirubin 1.2 mg/dL, ALT 487 U/L, Alk P not given], the enzyme elevations resolving within 6 weeks of stopping fenbendazole and despite continuing pembrolizumab). 34248555
Thakurdesai A, Rivera-Matos L, Nagra N, Busch B, Mais DD, Cave MC. Severe drug-induced liver injury due to self-administration of the veterinary anthelmintic medication, fenbendazole. ACG Case Rep J. 2024;11:e01354. (67 year old woman with colon cancer developed fatigue and jaundice a year after starting fenbendazole on her own to treat her cancer [bilirubin 13.3 rising to 24.0 mg/dL, ALT 2600 U/L, Alk P 141 U/L] her only other medications being chronic hormone replacement, liver tests improving after stopping fenbendazole and being normal 3 months later). 38706451
Nguyen J, Nguyen TQ, Han BO, Hoang BX. Oral fenbendazole for cancer therapy in humans and animals. Anticancer Res. 2024;44:3725-3735. (Extensive review of the literature on the mechanism of action, pharmacology, and laboratory and clinical evidence for the role of fenbendazole as therapy for cancer). 39197912
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, 5 [1%] were attributed to albendazole, 1 to mebendazole, but none to fenbendazole). 38992407
Reinhart JM. Drug-induced liver injury. Vet Clin North Am Small Anim Pract. 2025;55:717-730. (Review of the major causes of drug-induced liver injury in dogs and cats, discusses mebendazole but not fenbendazole). 40280782
Krishnan A, Lucas K, Maas L, Woreta TA. Differentiating fenbendazole-induced liver injury from immunotherapy hepatitis - the importance of structured causality assessment: A case report. World J Clin Cases. 2026;14:116700. (47 year old woman with metastatic colon cancer after several surgeries and chemotherapies, developed fatigue and dark urine while on nivolumab/relatlimab [Opdulag] for 9 months and 7 weeks after starting and 2 weeks after increasing the dose of fenbendazole [from 222 mg 4 days a week to daily] [bilirubin 3.1 mg/dL, ALT 2407 U/L, Alk P 215 U/L] resolving after stopping and later tolerating restarting the check point inhibitors). 41608149

## OTHER REFERENCE LINKS

1. Recent References on Fenbendazole: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Fenbendazole)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Fenbendazole: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=fenbendazole)